# Gold Preparations

## OVERVIEW

### Introduction

Gold salts, including auranofin and gold sodium thiomalate, have been used for the therapy of rheumatoid arthritis for many decades, but have recently been replaced by more modern disease-modifying antirheumatic drugs. Parenteral gold therapy (chrysotherapy) can cause acute, clinically apparent hepatitis that is usually cholestatic and self-limited in nature, but can be severe and even fatal. In contrast, oral gold preparations (such as auranofin) are associated with a low rate of serum enzyme elevations during treatment, but have not been convincingly linked to clinically apparent liver injury.

### Background

Gold given as a conjugate with thioglucose, thiosulphate or thiomalate salt has disease modifying activity in rheumatoid arthritis and can induce remission in up to 50% of patients. The mechanism of action is not well defined, but gold has clear antiinflammatory activity and lowers serum immunoglobulin levels. The use of gold as an antiinflammatory agent arose out of observations by Robert Koch who reported that gold salts had in vitro activity against mycobacterium tuberculosis. Trials of gold therapy in tuberculosis were unsuccessful, but clinically apparent antiinflammatory activity was found during treatment of patients with discoid lupus erythematosus, which at that time was believed to be due to tuberculosis. Chrysotherapy was introduced in the treatment of rheumatoid arthritis in the 1930s and it became a common approach to management of severe rheumatoid arthritis until the 1960s, when it was gradually replaced by more modern forms of disease modifying antirheumatic drugs (DMARDs) such as methotrexate, leflunomide, d-penicillamine, hydroxychloroquine, sulfasalazine, enteracept and infliximab. Previous formulations of gold salts included a parenteral form as gold sodium thiomalate which was available as 50 mg/mL under brand names including Aurolate and Myochrysine (now no longer generally available in the United States). The recommended dose was 10 mg intramuscularly once weekly, gradually increasing to a maintenance dose of 25 to 50 mg weekly or every other week. An oral form of gold, auranofin (aw ran' o fin), continues to be available as capsules of 3 mg under the brand name of Ridaura, the recommended dose of which is 3 to 9 mg daily. Therapy with gold salts is often limited by toxicity, some of which is cumulative. The effect may take weeks to months to occur, but therapy should be discontinued after an accumulative dose of 1 gram if beneficial results are not achieved. Common side effects include abdominal discomfort, nausea, pruritus, skin rash, urticaria and proteinuria. Fatal instances of hypersensitivity reactions, renal dysfunction and bone marrow suppression have been reported.

### Hepatotoxicity

Therapy with parenterally administered gold salts was linked with instances of acute liver injury shortly after being introduced into therapy in the 1930s. The nature of the liver injury was not well defined. The more modern formulations of gold appear to have a lower overall incidence of toxicity, including hepatotoxicity. Mild elevations in serum aminotransferase levels are not infrequent during therapy with gold, but clinically apparent liver injury is rare and appears to be idiosyncratic in nature and has been reported only with parenteral gold therapy. The onset of injury is within 1 to 8 weeks of starting therapy and presents with fever and rash, followed by malaise, nausea, right upper quadrant pain, dark urine and jaundice. Pruritus can be prominent, and the typical pattern of serum enzyme elevations is cholestatic or mixed. Recovery may be delayed but is usually complete within 6 to 8 weeks. Transient thrombocytopenia and anemia can occur, particularly in children. Autoantibody formation is not typical, although patients with rheumatoid arthritis are prone to have preexisting autoantibodies. A less frequent pattern of injury from gold therapy is marked by acute hepatic necrosis, usually arising within 1 to 4 weeks of starting therapy with marked elevations in serum aminotransferase levels (20 to 100 fold) and minimal increases in alkaline phosphatase. These cases of acute hepatocellular injury may be associated with high doses of parenteral gold salts and can be severe and have resulted in fatalities. A striking phenomenon is that symptoms of arthritis frequently improve during acute hepatic injury whether due to gold therapy or viral hepatitis. The improvements, however, are transient and of no lasting benefit.

Likelihood score (parenteral gold preparations): A (well known cause of clinically apparent liver injury).

Oral gold therapy has been associated with transient, mild elevations in serum aminotransferase levels, but there have been no convincing cases of clinically significant liver injury linked to oral preparations. Thus, idiosyncratic acute liver injury due to auranofin must be very rare, if it occurs at all.

Likelihood score (oral gold preparations): E* (unlikely although suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The typical acute liver injury from parenteral gold therapy appears to be related to hypersensitivity and is often accompanied by other allergic manifestations such as fever, rash, lymphadenopathy and eosinophilia. Cases of short latency onset, acute hepatic necrosis due to injections of gold more closely resemble direct, acute toxicity and have been reported after acute intentional or unintentional overdose of gold salts.

### Outcome and Management

Most cases of jaundice from parenteral gold therapy are self-limited, although recovery may be prolonged. There is little evidence that chelation improves outcome or speeds recovery, although it is often used with acute overdose of a gold containing compound. Rare instances of acute hepatic necrosis soon after initiation of gold therapy have been reported, some of which have been fatal. Rechallenge after clinically apparent hepatotoxicity can lead to severe recurrence and should be avoided. In situations of mild serum aminotransferase elevations during gold therapy, reinstitution of treatment without recurrent elevations is typical.

Drug Class: Antirheumatic Agents

## CASE REPORTS

### Case 1. Acute cholestatic hepatitis due to gold therapy in a child.

[Modified from: Ghisolfi J, Rumeau JL, Rolland M, Dalous A. [Cholestatic syndrome following massive chrysotherapy]. Arch Fr Pediatr 1972; 29: 1097-106. French. PubMed Citation (http://www.ncbi.nlm.nih.gov/pubmed/4662281)]

A 10 year old boy with suspected juvenile idiopathic (rheumatoid) arthritis was started on parenteral gold therapy in a dose of 40 mg daily for eight days (in error, as it was meant to be given twice weekly) and developed fever, rash and headaches by day nine, followed by severe nausea and vomiting leading to electrolyte imbalance and dehydration. Three days after stopping the gold injections, he was found to be jaundiced with pruritus, dark urine and light stools. The serum bilirubin was 14.6 mg/dL, alkaline phosphatase 630 U/L and ALT 130 U/L (Table). His fever and rash persisted for a week, but then improved rapidly with prednisone therapy. He remained jaundiced for a month with symptoms of pruritus and prominent elevations in serum alkaline phosphatase. A liver biopsy showed intrahepatic cholestasis. Electron microscopy demonstrated scattered gold particles in lysosomes of Kupffer cells and hepatocytes. Over the following 4 weeks the jaundice cleared and, by 6 weeks, laboratory abnormalities had returned to normal. His arthritis was managed with indomethacin.

#### Key Points

Medication: | Aurothiopropanol sulfonate (total dose of 200 mg over 8 days)
Pattern: | Cholestatic (R=~1.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 9 days to fever and rash, 11 days to jaundice
Recovery: | 6 weeks
Other medications: | Indomethacin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
14 days | 5 days | 130 | 630 | 14.6 | Fever and rash
17 days | 8 days | 480 | 960 | 9.6
19 days | 10 days | 480 | | 9.8
26 days | 17 days | 370 | 1240 | 8.7 | Prednisone started
35 days | 24 days | 400 | 1350 | 8.2
6 weeks | 5 weeks | 240 | 1150 | 7.9
7 weeks | 6 weeks | 83 | 620 | 5.7
8 weeks | 7 weeks | 77 | 570 | 28
12 weeks | 11 weeks | 35 | 400 | 1.2
Normal Values | | <40 | | <1.2

#### Comment

A cholestatic hepatitis in a child arising within a few days of stopping an 8 day course of gold therapy. The dose of gold was excessive and was meant to be given twice weekly rather than daily. Nevertheless, the pattern of injury was typical of a hypersensitivity reaction with fever and rash (DRESS syndrome, although no mention made of eosinophil counts). While the rash and fever appeared to respond to prednisone therapy, the jaundice was more persistent. Chelation therapy was not used.

### Case 2. Acute cholestatic hepatitis due to gold therapy in an adult.

[Modified from: Pessayre D, Feldmann G, Degott C, Ulmann A, Roger W, Erlinger S, Benhamou JP. Gold salt-induced cholestasis. Digestion 1979; 19: 56-64. PubMed Citation (http://www.ncbi.nlm.nih.gov/pubmed/156659)]

A 66 year old woman with suspected rheumatoid arthritis was treated with parenteral injections of gold salts twice weekly for 4 weeks and developed nausea and vomiting followed by rash, jaundice and pruritus. She had no history of liver disease and did not drink alcohol. No mention was made of other medications being taken. On presentation, the serum bilirubin was 32.5 mg/dL, ALT 550 U/L, and alkaline phosphatase 72 Bodansky units (16-fold elevated) (Table). Her jaundice worsened despite stopping gold therapy. ERCP showed a normal biliary tract, and liver biopsy showed marked intrahepatic cholestasis. The rash became exfoliative and persisted for 2 months, while jaundice lasted for 3 months. More extensive evaluation of her joint complaints demonstrated Waldenstrom’s macroglobulinemia with involvement of the knee joint. When seen in follow up 9 months later for recurrence of arthritis, she was anicteric and asymptomatic of liver disease, but had mild elevations in alkaline phosphatase.

#### Key Points

Medication: | Aurothiopropanol sulfonate (total dose of 200 mg over 4 weeks)
Pattern: | Cholestatic (R=0.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | 6 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
5 weeks | 1 week | | 30 | 12.5
6 weeks | 2 weeks | 550 | 72 | 32.5 | Admission
7 weeks | 3 weeks | 360 | 55 | 48.0
8 weeks | 4 weeks | 180 | 52 | 40.0
9 weeks | 5 weeks | 100 | 30 | 13.0
10 weeks | 6 weeks | 90 | 26 | 2.0 | Discharged
5 months | 4 months | 50 | 8 | <1.0
8 months | 7 months | 40 | 6 | <1.0 | Follow up
Normal Values | | <45 | <5 | <1.2

* Times and laboratory values are estimated from Figure 3. BU=Bodansky units.

#### Comment

A cholestatic hepatitis in an adult with rheumatoid arthritis arising after 4 weeks of therapy with twice-weekly injections of gold. Rash and eosinophilia were prominent, but fever was not mentioned. The cholestasis was prolonged, lasting for almost three months and with minor elevations in alkaline phosphatase still present months later when she was seen for an exacerbation of her rheumatoid arthritis. The residual alkaline phosphatase elevation was attributed to involvement of the liver by Waldenstrom’s macroglobulinemia.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Auranofin - Generic, Ridaura®

Gold Sodium Thiomalate - Generic, Aurolate®, Myochrysine®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Auranofin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Auranofin | 34031-32-8 | C20-H34-Au-O9-P-S | SID:134999267
Gold Sodium Thiomalate | 39377-38-3 | C4-H5-Au-O4-S.H2-O.2Na | SID:135030803

## ANNOTATED BIBLIOGRAPHY

References updated: 02 August 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; in early era chrysotherapy, reports of liver injury were common, but with more modern forms of gold, hepatotoxicity is rare; dermatitis, renal injury and myelotoxicity are more frequent side effects).
Lewis JH. Stine JG. Gold salts. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 388. (Review of liver injury due to gold; cholestatic injury is the characteristic lesion, probably immunologically mediated).
Burke A, Smyth E, FitzGerald GA. Analgesic-antipyretic and antiinflammatory agents: pharmacotherapy of gout. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 671-715. (Textbook of pharmacology and therapeutics; gold is now rarely used and has been replaced by more modern disease modifying antirheumatic drugs).
Drive JR, Weller JN. Untoward results from the use of gold compounds. Results of a fatal case. Arch Derm Syph 1931; 23: 87-109. Not in PubMed (23 page case report and review of the literature of adverse effects of gold therapy; 41 year old with lupus erythematosis developed fever and rash after 2nd injection of gold thiosulphate followed by confusion, jaundice, diffuse bleeding, coma and death).
Hartfall SJ, Garland HG. Further observations on the gold treatment of rheumatoid arthritis. Lancet 1936; 1: 1459-63. Not in PubMed (Among 300 patients with rheumatoid arthritis treated with gold injections [provided by "Messrs Schering and Bayer"], 37% had toxic reactions, including 11 [1%] with jaundice).
Hartfall SJ, Garland HG, Goldie W. Gold treatment of arthritis. Lancet 1937; 2: 838-42. Not in PubMed (Among 900 cases of rheumatic conditions [rheumatoid and osteoarthritis, ankylosing spondylitis and others] treated with gold, adverse events occurred in 42% and were severe in 6%; jaundice in 85 [9.4%], which was severe in 13 [1.4%] and fatal in 2; often during first course, not recurring with retreatment; some cases may have represented coincidental acute viral hepatitis).
Hartung EF. The treatment of rheumatoid arthritis including gold salts therapy. Bull N Y Acad Med 1943; 19: 693-703. (Review of role of gold in management of rheumatoid arthritis; given parenterally in courses of up to 1-2 grams cumulative, with 2-3 months between courses; no benefit if first course is not effective; remissions in 54% of patients; lists toxic hepatitis as a rare side effect). 19312340
Hartung EF. Toxic hepatitis during gold salt therapy: its effect on the course of rheumatoid arthritis. Med Clin North Am 1946; 30: 553-61. Not in PubMed (Among 800 patients with rheumatoid arthritis treated with gold, only 2 developed jaundice; symptoms of arthritis improved in half of patients who developed liver injury during gold therapy, but the improvement was only partial and transient only). 20983788
Schwartz S, Blain HR, Geiger HB, Hartung EF. Investigation of use of aurothioglycanide (Lauron) in rheumatoid arthritis: preliminary report of toxicity and therapeutic effects of a fine suspension. J Am Med Assoc 1954; 154: 1263-5. (Among 56 patients with rheumatoid arthritis treated with aurothioglycanide injections, 14% developed rash but none were severe, 1 developed thrombocytopenia, no mention of liver injury). 13151835
Moeschlin S, Siegenthaler P. [Cholestatic hepatitis caused by gold; analogy to chlorpromazine and androgen icterus.] Helv Med Acta 1960; 27: 707-15. (47 year old woman with rheumatoid arthritis developed nausea and jaundice 3 weeks after starting gold therapy with prolonged jaundice and pruritus [bilirubin 7.5 rising to 24 mg/dL, Alk P 2-3 times ULN, ALT 134 U/L, 2% eosinophils on corticosteroids], laparotomy and liver biopsy showing intrahepatic cholestasis). 13771657
Empire Rheumatism Council Research Sub-Committee. Gold therapy in rheumatoid arthritis. Final report of a multicenter controlled trial. Ann Rheum Dis 1961; 20: 315-34. Not in PubMed (In a controlled trial of aurothiomalate in 185 patients with rheumatoid arthritis with 2 years of follow up, 35% had side effects; usually rash [20%], purpura, proteinuria, fever and gastrointestinal upset; no mention of liver injury). 18623862
Wiontzek H, Schmidt J. [Allergic cholestatic hepatosis following gold treatment of a seronegative, chronic progressive polyarthritis]. Z Rheumaforsch 1970; 29: 46-8. German. (50 year old woman developed an allergic reaction after 43 days of gold therapy with eosinophilia [35%] and minor elevations of Alk P [170 U/L] and ALT [41 U/L] without jaundice, resolving in 2 weeks). 5420462
Kornreich H, Malouf NN, Hanson V. Acute hepatic dysfunction in juvenile rheumatoid arthritis. J Pediatr 1971; 79: 27-35. (7 children with juvenile idiopathic [rheumatoid] arthritis developed acute hepatic injury from various causes; ages 2-8 years, 5 with jaundice, all had transient remission during peak of injury regardless of cause with decrease in ESR and rheumatoid factor; 3 cases were receiving gold therapy and several others were on high doses of aspirin or indomethacin). 5314582
Ghisolfi J, Rumeau JL, Rolland M, Dalous A. [Cholestatic syndrome following massive chrysotherapy]. Arch Fr Pediatr 1972; 29: 1097-106. French. (10 year old boy given 40 mg of gold daily for 8 days, developed rash, vomiting, fever and jaundice [bilirubin 14.6 mg/dL, Alk P 630 rising to 1350 U/L, ALT 150 U/L], resolving within 6 weeks of stopping; gold identified in liver biopsy in lysosomes of Kupffer cells and hepatocytes: Case 1). 4662281
Gigante D. [Collateral effects of gold salts in the therapy of rheumatoid arthritis]. Clin Ter 1972; 60: 321-32. Italian. 5023985
Iuel J. [Deaths from gold therapy in Denmark during 1960-64]. Ugeskr Laeger 1973; 135: 1639-42. Danish. (Among 10 reports of fatalities attributed to gold, 2 were due to liver injury: 82 year old woman with mixed connective tissue disease had onset of fever and jaundice 3 days after initial injection and died 15 days later; 14 year old boy with juvenile idiopathic [rheumatoid] arthritis who developed fever and jaundice 2 days after the second injection and died 7 days later). 4271249
Schenker S, Olson KN, Dunn D, Breen KJ, Combes B. Intrahepatic cholestasis due to therapy of rheumatoid arthritis. Gastroenterology 1973; 64: 622-9. (Two case reports; 66 year old man with rheumatoid arthritis developed jaundice after third weekly injection of gold [bilirubin 7.6 mg/dL, ALT 73 U/L, Alk P 10 times ULN], with complete resolution over next 2 months; 34 year old woman with rheumatoid arthritis developed rash and jaundice after fourth weekly injection of gold [bilirubin 12 rising to 45 mg/dL, AST 83 U/L, Alk P 5 times ULN], with prolonged jaundice and pruritus for 6 months and abnormal Alk P 2 years later). 4633722
Cuthbert MF. Adverse reactions to non-steroidal antirheumatic drugs. Curr Med Res Opin 1974; 2: 600-10. (Summary of adverse reaction reports on rheumatologic agents from UK; 102 reports on gold over 10 year period, 32 being fatal; mostly blood disorders, no mention of hepatotoxicity). 4452298
Favreau M, Tannenbaum H, Lough J. Hepatic toxicity associated with gold therapy. Ann Intern Med 1977; 87: 717-9. (Three cases of liver injury due to gold therapy in patients with rheumatoid arthritis; women, ages 50-59 years, onset of jaundice 20-40 days after starting gold injections, peak bilirubin 7.1-11.7 mg/dL, AST 62-230 U/L, Alk P 5-7 times ULN, fever in 1, eosinophilia in 2, slow but complete recovery in all). 412451
Prichanond S, Skosey JL. Gold and liver biopsy. Ann Intern Med 1978; 88: 579. (44 year old woman with rheumatoid arthritis developed large lymph nodes, hepatomegaly and pulmonary infiltrates after 135 mg of gold injections with eosinophilia, but minimal to no elevation in AST, Alk P or bilirubin, slowly resolved and liver biopsy was unrevealing). 416737
Fossati C. [Side-effects and toxic effects of gold salts]. Clin Ter 1979; 91: 407-20. Italian. 161525
Ghishan FK, LaBrecque DR, Younoszai K. Intrahepatic cholestasis after gold therapy in juvenile rheumatoid arthritis. J Pediatr 1978; 93: 1042-3. (Child with juvenile idiopathic [rheumatoid] arthritis developed fever, rash and abdominal pain 48 hours after second injection of gold [bilirubin 13 mg/dL, ALT 120 U/L, Alk P 575 U/L], resolving within 8 weeks of stopping). 102752
Panayi GS, Wooley P, Batchelor JR. Genetic basis of rheumatoid disease: HLA-antigens, disease manifestations, and toxic reactions to drugs. Brit Med J 1978; 2: 1326-8. (Among 95 patients with rheumatoid arthritis, 56% had DRW4 [vs 33% of controls], minor associations of toxicity to gold or penicillamine in subjects with DRW2 or 3; no mention of hepatotoxicity). 719380
Pessayre D, Feldmann G, Degott C, Ulmann A, Roger W, Erlinger S, Benhamou JP. Gold salt-induced cholestasis. Digestion 1979; 19: 56-64. (66 year old woman with rheumatoid arthritis developed jaundice 4 weeks after starting parenteral gold therapy [bilirubin 32.5 mg/dL, ALT 550 U/L, Alk P 14 times ULN, eosinophils 1,400/µL], slow resolution and mild Alk P abnormalities 9 months later: Case 2). 156659
Griffin AJ. Cholestatic hepatitis induced by gold. Rheumatol Rehabil 1979; 18: 174-6. (55 year old man with rheumatoid arthritis developed jaundice 14 days after starting gold therapy [peak bilirubin 4.9 mg/dL, AST 82 U/L, Alk P 918 U/L], worsening for 1 week and then resolving). 115078
Alcalay M, Touchard G, Patte F, Babin P, Reboux JF, Thomas P, Patte D, et al. [Simultaneous nephropathy, lung disease and liver disease caused by gold salts, with an ultrastructural study of pulmonary and renal lesions]. Rev Rhum Mal Osteoartic 1979; 46: 491-8. French. 504952
Kean WF, Anastassiades TP. Long term chrysotherapy: incidence of toxicity and efficacy during sequential time periods. Arthritis Rheum 1979; 22: 495-501. (Among 94 patients with rheumatoid arthritis treated with gold at a single clinic, 70% had clinical benefit, 42 had to be withdrawn because of toxicity: rash in 45%, mouth ulcers in 20%, proteinuria 19%; 2 instances of jaundice after 85 and 75 mg, resolving in 6 weeks and tolerated restarting). 156026
Wilson DB, Korn JH. Acute toxicity from an overdose of gold. J Rheumatol 1979; 6: 359-61. (33 year old woman with rheumatoid arthritis treated with gold for 4 years, received single dose of 500 mg by error, immediately developing headache, flushing and nausea with transient thrombocytopenia [platelet nadir: 83,000/µL] and mild serum enzyme elevations [ALT 70 U/L], resolving in 4 days). 114637
Gibbons RB. Complications of chrysotherapy: a review of recent studies. Arch Intern Med. 1979; 139: 343-6. (Review of side effects of gold therapy; hepatic injury is rare but well defined, usually cholestatic and self-limited, but recovery may be slow). 371565
Davis P. Undesirable effects of gold salts. J Rheumatol Suppl 1979; 5: 18-24. (Review of major complications of gold therapy including myelosuppression, nephrotic syndrome, dermatitis; under miscellaneous, cholestatic hepatitis is mentioned; chelation therapy of uncertain benefit). 290813
Chalès G, Grosbois B, Pawlotsky Y, Louboutin JY, Gueguen A, Estable P. [Neurological and hepatic complications in chrysotherapy (author's transl)]. Sem Hop 1980; 56: 1787-92. French. 6256879
Bene E, Megyeri A, Györi J. [Gold therapy in chronic polyarthritis. Differentiation of allergic and toxic side effects]. Z Rheumatol 1980; 39: 109-16. German. 6448525
Charhon S, Rouillat M, Bouvier M. [Hepatitis caused by gold therapy: a case]. Rev Rhum Mal Osteoartic 1980; 47: 205. French. (67 year old woman with rheumatoid arthritis developed rash after two gold injections followed by fever and jaundice [bilirubin 4.5 mg/dL, ALT 180 U/L, Alk P 756 U/L], resolving within 6 weeks of stopping). 7384728
Wooley PH, Griffin J, Panayi GS, Batchelor JR, Welsh KI, Gibson TJ. HLA-DR antigens and toxic reactions to sodium-aurothiomalate and D-penicillamine in patients with rheumatoid arthritis. N Engl J Med 1980; 303: 300-2. (HLA testing on another 91 patients with rheumatoid arthritis found DRw3/HLA B8 in 14 of 15 patients who developed proteinuria on gold or penicillamine therapy; DRw4 in 54% of patients). 6770269
Frigerio G, Terruzzi V, Butti GC, Minoli G, Rossini A. [Toxic cholestatic hepatitis secondary to chrysotherapy]. Minerva Med 1981; 72: 1941-4. Italian. (57 year old woman with rheumatoid arthritis developed jaundice shortly after fourth weekly injection of gold [bilirubin 3.6 mg/dL, ALT 340 U/L , Alk P 120 U/L, eosinophils 1%], biopsy showing intrahepatic cholestasis, resolving in 6 weeks). 7254640
Le Bodic MF, Degott C, Barrier J, Chekroun G, Gaillard F, Couprie F, Mussini-Montpellier J. [Anatomo-pathologic aspects of gold-salt induced cholestasis. Report of two cases with ultrastructural study (author's transl)]. Arch Anat Cytol Pathol 1981; 29: 98-104. French. (Two cases: 48 year old man with rheumatoid arthritis developed fever and malaise after first two injections of gold and jaundice after the third [bilirubin 2.7 mg/dL, ALT 75 U/L, Alk P 165 U/L, eosinophils 1,078/µL], with rapid and complete recovery; 66 year old woman with rheumatoid arthritis developed rash and jaundice 1 week after 4 week course of gold [bilirubin 32.5 mg/dL, ALT 550 U/L, Alk P 12 times ULN, eosinophils 1,400/µL], recovery in 3 months, but Alk P still elevated 10 months later). 7235755
Howrie DL, Gartner JC Jr. Gold-induced hepatotoxicity: case report and review of the literature. J Rheumatol 1982; 9: 727-9. (3 year old girl with juvenile idiopathic [rheumatoid] arthritis developed rash, fever, lymphadenopathy and jaundice after 2nd injection of gold sodium thiomalate [bilirubin 4.0 mg/dL, AST 240 U/L, platelets 87,000/µL], rapid recovery). 6217328
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 reports of drug induced liver injury from Denmark between 1968 and 78, 2% were attributed to gold therapy). 6982502
Korneĭchuk AV, Kushnir LV. [Case of drug (krizanol) hepatitis]. Vrach Delo 1982; 2: 41-2. Russian. 7064450
Sanchis Closa A, Caballeria Rovira E, Arago Lopez JV, Sune Gispert S. [Submassive hepatic necrosis due to treatment with gold salts]. Gastroenterol Hepatol 1983; 6: 468-70. Spanish. Not in PubMed (32 year old woman with rheumatoid arthritis developed jaundice 6 months after starting gold therapy with aurothioglucose [bilirubin 2.4 mg/dL, ALT 400 U/L]; therapy was continued for another 2 months when she developed exfoliative rash and purpura [bilirubin 2.8 mg/dL, ALT 175 U/L, Alk P 5 times ULN] and bone marrow failure leading to death 17 days later; postmortem liver biopsy reportedly showed massive hepatic necrosis).
Gran JT, Husby G, Thorsby E. HLA DR antigens and gold toxicity. Ann Rheum Dis 1983; 42: 63-6. (Among 132 patients with rheumatoid arthritis treated with gold, 65% had adverse reactions, 42% rash, 11% proteinuria and 3.8% liver injury; the 16 patients with HLA DR3 had higher rates of adverse reactions including 44% with proteinuria and 13% liver reactions). 6402993
Ward JR, Williams HJ, Egger MJ, Reading JC, Boyce E, Altz-Smith M, Samuelson CO Jr, et al. Comparison of auranofin, gold sodium thiomalate, and placebo in the treatment of rheumatoid arthritis. A controlled clinical trial. Arthritis Rheum 1983; 26: 1303-15. (Controlled trial of oral auranofin vs parenteral gold sodium thiomalate vs placebo in 193 patients with rheumatoid arthritis; 3 patients [4%] on gold injections, but none on oral gold or placebo had ALT elevations on therapy, which fully resolved on stopping). 6416259
Edelman J, Donnelly D, Graham N, Percy JS. Liver dysfunction associated with gold therapy for rheumatoid arthritis. J Rheumatol 1983; 10: 510-1. (Three cases: 65, 61 and 56 year old women with rheumatoid arthritis developed symptoms of liver injury [jaundice, nausea and pruritus] after 8, 12 and 2-3 weeks of gold sodium thiomalate therapy [bilirubin 32.8, 8.8 and 2.0 mg/dL, AST 61, 151 and 50 U/L, Alk P 355, 635 and 350 U/L], recovery in 1-3 months, but persistent Alk P elevations still present in all 3 when last seen 5-20 weeks after stopping gold). 6411922
Lewis D, Madhok R, Capell H. Liver dysfunction associated with gold therapy for RA. J Rheumatol 1984; 11: 395-6. (72 year old woman with rheumatoid arthritis developed jaundice 3-4 weeks after starting gold therapy [bilirubin 7.1 mg/dL, ALT 169 U/L, Alk P 2890 U/L], resolving within 1 month). 6429329
Rainer F. [Undesirable effects of gold therapy]. Wien Klin Wochenschr Suppl 1984; 156: 40-4. German. (Review of side effects of gold therapy; rare but severe complications of gold therapy are pulmonary fibrosis, aplastic anemia, thrombocytopenia, leukopenia, neuropathy, loss of hair, nail changes and cholestatic liver injury, these being "extremely uncommon or no more than anecdotal"). 6442056
Shaban MR, Golding DN, Letcher RG. Fatal intrahepatic cholestasis and interstitial lung fibrosis following gold therapy for rheumatoid arthritis. J R Soc Med 1984; 77: 960-1. (53 year old woman with rheumatoid arthritis developed fever after a second injection of gold with progressive pneumonitis and jaundice arising 2 days later [bilirubin 6.5 mg/dL, AST 198 U/L, Alk P 2080 U/L, 8% eosinophils] and death within days; autopsy showed centrolobular necrosis and cholestasis). 6438309
Smith MD, Brooks PM. Gold compounds in rheumatic diseases-2. Med J Australia 1984; 140: 77-81. (Review on use of gold in rheumatoid arthritis; side effects occur in 50% of patients, skin rashes in 24%, stomatitis in 11%, proteinuria in 10%, and thrombocytopenia in 4%; pneumonitis and hepatitis from gold are rare). 6607399
Schapira D, Nahir M, Scharf Y, Pollack S. Cholestatic jaundice induced by gold salts treatment clinical and immunological aspects--report of one case and review of the literature. J Rheumatol 1984; 11: 843-5. (56 year old woman with rheumatoid arthritis developed rash and jaundice 4 weeks after starting aurothioglucose [bilirubin 10.8 mg/dL, AST 95 U/L, Alk P 1525 U/L], with positive in vitro lymphocyte stimulation tests to gold). 6440983
Jaeger A, Porte A, Sauder P, Stoeckel ME, Mantz JM. [Hepatitis secondary to a gold salt overdose]. Gastroenterol Clin Biol 1984; 8: 660-6. French. (51 year old woman with rheumatoid arthritis mistakenly took an overdose of aurothiopropanol sulfonate [300 mg gold] and two weeks later developed fever and jaundice [bilirubin peak 11 mg/dL, ALT 665 U/L, Alk P 2020 U/L, 1,400/µL eosinophils], resolving with 6 weeks of stopping). 6489687
Lowthian PJ, Cleland LG, Vernon-Roberts B. Hepatotoxicity with aurothioglucose therapy. Arthritis Rheum 1984; 27: 230-2. (43 year old woman with rheumatoid arthritis developed lymphadenopathy followed by lethargy and dark urine, rash and eosinophilia 2 weeks after starting aurothioglucose injections [bilirubin 1.2 mg/dL, AST 166 U/L, Alk P 542 U/L], resolving within 2 months). 6421293
Harats N, Ehrenfeld M, Shalit M, Lijovetzky G. Gold-induced granulomatous hepatitis. Isr J Med Sci 1985; 21: 753-6. (53 year old woman with rheumatoid arthritis developed jaundice and pruritus without rash or fever 3 weeks after starting aurothioglucose [bilirubin 4.4 mg/dL, ALT 356 U/L, Alk P 344 U/L], liver biopsy showing intrahepatic cholestasis and a few small, foamy granulomas). 3932253
Hadchouel M, Prieur AM, Griscelli C. Acute hemorrhagic, hepatic, and neurologic manifestations in juvenile rheumatoid arthritis: possible relationship to drugs or infection. J Pediatr 1985; 106: 561-6. (7 French children with juvenile idiopathic [rheumatoid] arthritis developed sudden onset of fever, vomiting, drowsiness, with gastrointestinal hemorrhagic and liver abnormalities, with marked elevations in ALT and prothrombin time, two died, several were treated with corticosteroids, 3 had onset soon after starting parenteral gold therapy). 3981309
Hanissian AS, Rothschild BM, Kaplan S. Gold: hepatotoxic and cholestatic reactions. Clin Rheumatol 1985; 4: 183-8. (Four cases of jaundice arising during gold therapy of juvenile or adult rheumatoid arthritis with few specific details; all resolved rapidly with stopping therapy). 3924468
Hochberg MC. Auranofin or d-penicillamine in the treatment of rheumatoid arthritis. Ann Intern Med 1986; 105: 528-35. (Controlled trial of 12 months of auranofin vs penicillamine in 90 patients with rheumatoid arthritis; withdrawal rate was 40%; abnormal liver tests [>2 times ULN] occurred in 11% vs 7%). 3092712
Smith MD. Hepatitis and neutropenia secondary to gold thiomalate therapy for rheumatoid arthritis. Aust N Z J Med 1986; 16: 72-4. (37 year old woman with rheumatoid arthritis developed jaundice after 80 mg of gold therapy [bilirubin ~19 mg/dL, AST ~230 U/L, Alk P ~150 U/L, 5% eosinophils], with recurrence and severe neutropenia upon rechallenge). 3085648
Schapira D, Nahir AM. [Chrysotherapy induced hepatic damage]. Harefuah 1986; 110: 14-5. Hebrew. 3082727
Tozman ECS, Gottlieb NL. Adverse reactions with oral and parenteral gold preparations. Med Toxicol 1987; 2: 177-89. (In the US, 2 parenteral gold formulations [aurothioglucose and aurothiomalate] and one oral form [auranofin: triethylphosphine gold] are available; indications are progressive rheumatoid arthritis). 3298922
Tebib J, Colson F, Noël E, Bouvier M. [A new case of gold-induced hepatitis during the treatment of rheumatoid polyarthritis]. Rev Rhum Mal Osteoartic 1988; 55: 705-7. French. 3142032
Farre JM, Perez T, Hautefeuille P, Tonnel F, Colombel JF, Duquesnoy B, Delcambre B. Cholestasis and pneumonitis induced by gold therapy. Clin Rheumatol 1989; 8: 538-40. (70 year old man with rheumatoid arthritis developed rash and fever after 3 weeks of weekly gold injections [bilirubin 10.4 mg/dL, ALT normal, Alk P 990 U/L]; biopsy showed intrahepatic cholestasis, lymphocyte stimulation tests to gold was positive, resolution within 12 weeks). 2612124
Watkins PB, Schade R, Mills AS, Carithers RL Jr, Van Thiel DH. Fatal hepatic necrosis associated with parenteral gold therapy. Dig Dis Sci 1988; 33: 1025-9. (2 cases of severe hepatotoxicity from gold in patients with seronegative rheumatoid arthritis: 33 year old man developed abdominal pain, fever and jaundice 1 day after second injection of aurothioglucose [bilirubin 20.7 mg/dL, ALT 2380 U/L, Alk P 342 U/L, protime 3 sec prolonged], with ascites and progressive coma leading to liver transplantation; 23 year old man developed fatigue and jaundice 2 months after starting aurothiomalate [bilirubin 7.7 mg/dL, ALT 2760 U/L, Alk P 397 U/L, protime 6 sec prolonged], with progressive hepatic failure and death). 3134176
González Pérez JA, Calvo Catala J, Herrera Bataller A, Hortelano Martínez E, Folgado Montesinos J, López Maldonado MD. [Mixed hepatopathy due to parenteral gold salts]. An Med Interna 1990; 7: 477-9. Spanish. 1983295
Hansen RM, Varma RR, Hanson GA. Gold induced hepatitis and pure red cell aplasia. Complete recovery after corticosteroid and N-acetylcysteine therapy. J Rheumatol 1991; 18: 1251-3. (54 year old man with psoriatic arthritis developed jaundice 4 weeks after starting gold sodium thiomalate injections [bilirubin peak 26 mg/dL, ALT 310 U/L, Alk P 1372 U/L], followed by pure red cell aplasia, liver injury resolving in 6 weeks and anemia in 8 weeks). 1941835
Singh G, Fries JF, Williams CA, Zatarain E, Spitz P, Bloch DA. Toxicity profiles of disease modifying antirheumatic drugs in rheumatoid arthritis. J Rheumatol 1991; 18: 188-94. (Analysis of side effects of 7 agents from the ARAMIS database including 2,479 patients [582 on parenteral and 322 on oral gold] with rheumatoid arthritis reported no instances of liver abnormalities or jaundice during ~1230 patient years of exposure). 1673721
Van Linthoudt D, Buss W, Beyner F, Ott H. [Fatal hepatic necrosis due to a treatment course of rheumatoid arthritis with gold salts]. Schweiz Med Wochenschr 1991; 121: 1099-102. French. 1678206
Fleischner GM, Morecki R, Hanaichi T, Hayashi H, Quintana N, Sternlieb I. Light- and electron-microscopical study of a case of gold salt-induced hepatotoxicity. Hepatology 1991; 14: 422-5. (56 year old woman with rheumatoid arthritis developed jaundice after 8 years of intermittent gold therapy [bilirubin 10.2 mg/dL, ALT 487 U/L, Alk P 99 U/L], biopsy showed submassive necrosis and inflammation but no mention of fibrosis, slow improvement and persistence of ALT elevations 10 months after stopping). 1908434
Yamanishi Y, Takeda M, Honjo N, Aoi K, Ishibe Y, Yamana S. [Gold-induced severe cholestatic jaundice in rheumatoid arthritis patient and effect of repeated steroid pulse therapy]. Ryumachi 1992; 32: 475-82. Japanese. 1440084
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Among 1188 liver adverse drug reaction reports in Denmark between 1979 and 1987, gold accounted for 19 [1.6%] overall including 2 of 52 fatal cases [4%]). 1506809
Brass EP. Hepatic toxicity of antirheumatic drugs. Cleve Clin J Med 1993; 60: 466-72. (Short review of hepatotoxicity of nonsteroidals, salicylates, methotrexate, penicillamine and gold). 8287508
Rye B, Krusinski PA. Hepatonecrosis resulting from parenteral gold therapy in pemphigus vulgaris. J Am Acad Dermatol 1993; 28: 99-101. (62 year old woman with pemphigus vulgaris developed jaundice 3 weeks after starting gold sodium thiomalate [bilirubin 6.7 mg/dL, ALT 1265 U/L, Alk P 308 U/L, no eosinophils], resolving in 8 weeks on dexamethasone). 8425980
Nisar M, Winfield J. Gold induced colitis and hepatic toxicity in a patient with rheumatoid arthritis. J Rheumatol 1994; 21: 938-9. (40 year old woman with rheumatoid arthritis developed rash and jaundice after 4 weeks of aurothiomalate injections [bilirubin 7.5 mg/dL, AST 68 U/L, Alk P 320 U/L, eosinophils normal], with colitis leading to laparotomy and partial colectomy; cholestasis resolved within 2 months, but minor Alk P elevations persisted). 8064738
Bendix G, Bjelle A. A 10 year follow up of parenteral gold therapy in patients with rheumatoid arthritis. Ann Rheum Dis 1996; 55: 169-76. (Long term outcome on 376 patients with rheumatoid arthritis treated with gold, high rate of discontinuation ~42% at 1, 55% at 2, 74% at 5 and 92% by 10 years; mucocutaneous side effects were most common reason for stopping therapy; one patient died of acute liver failure after 9 months of gold therapy, cause uncertain). 8712879
Bustabad Reyes S, González García T, Trujillo Martín E, Gantes Mora M, Rodríguez-Lozano B [Toxic effects of the second dose of sodium aurothiomalate in childhood systemic chronic arthritis]. An Esp Pediatr 1997; 46: 391-3. Spanish. 9214235
Tilelli JA, Heinrichs MM. Adverse reactions to parenteral gold salts. Lancet 1997; 349: 853. (71 year old woman with rheumatoid arthritis on weekly aurothioglucose for 9 months, developed anaphylaxis to single injection of aurothiomalate, with subsequent cerebrovascular accident and death). 9121270
Koryem HK, Taha KM, Ibrahim IK, Younes LK. Liver toxicity profile in gold-treated Egyptian rheumatoid arthritis patients. Int J Clin Pharmacol Res 1998; 18: 31-7. (40 Egyptian patients with rheumatoid arthritis treated with gold for at least 40 weeks underwent liver biopsy; 16 had fibrosis [Roenigk Grade IIIA or B], but none had "significant abnormal deviations" in ALT and AST results). 9604732
Ben-Ami H, Pollack S, Nagachandran P, Lashevsky I, Yarnitsky D, Edoute Y. Reversible pancreatitis, hepatitis, and peripheral polyneuropathy associated with parenteral gold therapy. J Rheumatol 1999; 26: 2049-50. (63 year old man with rheumatoid arthritis developed abdominal pain, fever and jaundice 2-3 weeks after starting gold injections [bilirubin 7.1 rising to 25.8 mg/L, ALT 903 U/L, Alk P 298 U/L, amylase 967 U/L, no eosinophils], with appearance of polyneuropathy 2 weeks later and resolution over 4 months; lymphocyte stimulation test to gold was weakly positive). 10493691
te Boekhorst PA, Barrera P, Laan RF, van de Putte LB. Hepatotoxicity of parenteral gold therapy in rheumatoid arthritis: a case report and review of the literature. Clin Exp Rheumatol 1999; 17: 359-62. (62 year old man with rheumatoid arthritis developed jaundice 3 weeks after starting gold injections [bilirubin ~5.3 mg/dL, ALT 305 U/L, Alk P 210 U/L], resolving in 6 weeks). 10410273
van Jaarsveld CHM, Jahangier ZN, Jacobs JWG, Blaauw AAM, van Albada-Kuipers GA, ter Borg EJ, Brus HLM, et al. Toxicity of antirheumatic drugs in a randomized clinical trial of early rheumatoid arthritis. Rheumatology 2000; 39: 1374-82. (Controlled trial of 4 treatment strategies in 419 patients with early rheumatoid arthritis; side effects were common with ALT elevations in 5 patients on nonsteroidals only, 1 patient each on gold and hydroxychloroquine, and 20 patients on methotrexate). 11136881
Mok MY, Ng WL, Yuen MF, Wong RW, Lau CS. Safety of disease modifying anti-rheumatic agents in rheumatoid arthritis patients with chronic viral hepatitis. Clin Exp Rheumatol 2000; 18: 363-8. (Among 29 Chinese patients with rheumatoid arthritis and chronic hepatitis [23 HBV; 6 HCV], ALT elevations occurred in 41% on hydroxychloroquine, 30% on methotrexate and 14% on gold vs 14% of 94 controls without viral hepatitis). 10895374
Uhm WS, Yoo DH, Lee JH, Kim TH, Jun JB, Lee IH, Bae SC, et al. Injectable gold-induced hepatitis and neutropenia in rheumatoid arthritis. Korean J Intern Med. 2000; 15: 156-9. (62 year old woman with rheumatoid arthritis developed nausea and pruritus 2-3 weeks after starting gold therapy [bilirubin normal, ALT ~190 U/L, Alk P ~370 U/L], resolving within 4 weeks). 10992732
Wu ML, Tsai WJ, Ger J, Deng JF, Tsay SH, Yang MH. Cholestatic hepatitis caused by acute gold potassium cyanide poisoning. J Toxicol Clin Toxicol 2001; 39: 739-43. (27 year old man took overdose of gold potassium cyanide and was jaundiced one day later [bilirubin 5.6 mg/dL, ALT 273 U/L, Alk P 117 U/L], resolving over next 3 weeks). 11778673
Ciompi ML, Amoresano C, Balzarini P, Bazzichi LM, Broggini M, Buratti L, Calcagnile F, et al. [Sodium gold thiosulfate therapy: an open, viewed, multicenter trial in rheumatoid arthritis patients followed for two years]. Reumatismo 2002; 54: 251-6. Italian. (Among 126 patients with rheumatoid arthritis treated with gold sodium thiomalate for two years, liver test abnormalities accounted for dose discontinuations in ~2% of patients). 12404034
Basset C, Vadrot J, Denis J, Poupon J, Zafrani ES. Prolonged cholestasis and ductopenia following gold salt therapy. Liver Int 2003; 23: 89-93. (49 year old woman with suspected rheumatoid arthritis developed rash and jaundice one month after starting aurothiopropanol sulphonate injections [bilirubin 7 mg/dL, ALT 5 times, and Alk P 11 times ULN], biopsy showing bile duct injury, slow resolution, ductopenia in follow up liver biopsy). 12654130
Ujfalussy I, Koó E, Seszták M, Gergely P. Termination of disease-modifying antirheumatic drugs in rheumatoid arthritis and in psoriatic arthritis. A comparative study of 270 cases. Z Rheumatol 2003; 62: 155-60. (Among 206 patients treated with methotrexate, sulfasalazine or gold therapy, withdrawals due to toxicity and to elevated serum enzymes were more common in patients with psoriasis [47% and 11.5%] than rheumatoid arthritis [29% and 5.7%]). 12721703
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to gold). 15390328
Díaz J, Dávalos M, Román R, Bustíos C, Zumaeta E. [Hepatotoxicity and pancreatitis associated with gold salts: case report]. Rev Gastroenterol Peru 2004; 24: 353-6. Spanish. (Abstract; 37 year old woman with rheumatoid arthritis developed jaundice after 3 weeks of gold therapy). 15614305
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting System from 1966-2002; 103 cases identified as highly probable, probable or possible; none were attributed to gold). 16165719
Brenard R, Dumortier P, Del Natale M, Honhon B, Van Den Berghe M, Bataille C, Rickaert F, et al. Black pigments in the liver related to gold and titanium deposits. A report of four cases. Liver Int 2007; 27: 408-13. (Black pigment found in portal tract macrophages and Kupffer cells in liver biopsies from 4 patients with chronic cholestasis was shown to be gold in 3, two on long term gold therapy for rheumatoid arthritis and one who had no memory of receiving gold; a fourth patient had pigment in macrophages of granulomas that was shown to be titanium [bilateral knee replacements]). 17355464
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to gold). 18955056
Helliwell PS, Taylor WJ; CASPAR Study Group. Treatment of psoriatic arthritis and rheumatoid arthritis with disease modifying drugs comparison of drugs and adverse reactions. J Rheumatol 2008; 35: 472-6. (In a large multinational community based database of patients with psoriatic and rheumatoid arthritis, gold salts were used in 7-11%). 18203324
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, one was attributed to "gold salts" [Diaz 2004]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to gold salts). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Auranofin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Auranofin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Auranofin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Auranofin)